# Tivozanib

## OVERVIEW

### Introduction

Tivozanib is a small molecule multi-kinase inhibitor that is used in the treatment of relapsed or refractory renal cell carcinoma. Tivozanib is associated with transient and usually mild elevations in serum aminotransferase during therapy and but has not been linked instances of clinically apparent acute liver injury.

### Background

Tivozanib (tye voe’ za nib) is an orally available, small molecule multi-kinase inhibitor which is used as a third line treatment of relapsed or refractory renal cell carcinoma. Tivozanib inhibits multiple tyrosine kinases, including vascular endothelial growth factor receptor (VEGFR)-1, VEGFR-2, VEGFR-3, c-kit, and platelet derived growth factor receptor beta (PDGFR-β). These kinases are often overexpressed in cancer cells, and VEGFRs are frequently found in renal cell cancers. Tivozanib had growth inhibitory activity in vitro and in vivo against renal cell cancer cell lines. In a randomized controlled trial in patients with relapsed or refractory renal cell cancer, tivozanib was found to be associated with a longer progression free survival than sorafenib. On the basis of these results, tivozanib was approved in the United States in 2021 as therapy of patients with relapsed or refractory advanced renal cell carcinoma following two or more prior therapies. Tivozanib is available in capsules of 1.34 and 0.89 mg under the brand name Fotivda. The recommended dose is 1.34 mg once daily for 21 days of 28-day cycles to continue until disease progression or unacceptable toxicity. Common side effects include hypertension, and symptoms of fatigue, diarrhea, decreased appetite, nausea, dysphonia, cough, and stomatitis. Therapy is also associated with hypothyroidism and decreases in serum sodium and phosphate. Less common but potentially severe adverse events include severe hypertension and hypertensive crisis, heart failure, arterial and venous thrombotic events, hemorrhage, proteinuria, thyroid dysfunction, impaired wound healing, reversible posterior leukoencephalopathy, and embryo-fetal toxicity.

### Hepatotoxicity

In the published preregistration clinical trials of tivozanib, rates of serum ALT or AST elevations ranged from 10% to 29%, with 1% to 4% of treated patients having elevations above 5 times the upper limit of normal (ULN). Instances of clinically apparent liver injury including deaths with hepatic failure were reported in some clinical trials, but in all cases were attributed to hepatic metastases or to other underlying liver diseases. Since its approval and more widespread clinical use, there have been no reports of clinically apparent liver injury or hepatic failure attributed to tivozanib, but it has had limited clinical use.

Likelihood score: E* (unproven but suspected cause of clinically apparent liver injury).

### Mechanism of Injury

Tivozanib therapy has been clearly linked to serum enzyme elevations the cause of which is unknown, but similar rates and patterns of liver test abnormalities have been reported with many kinase inhibitors and particularly with multi-kinase inhibitors such as tivozanib. Tivozanib is metabolized in the liver largely by CYP 3A and liver injury may be due to metabolism to an immunogenic or toxic intermediate. Tivozanib is also susceptible to drug-drug interactions with inducers or inhibitors of CYP 3A4.

### Outcome and Management

Tivozanib has been clearly linked to serum aminotransferase elevations but has not been clearly linked to clinically apparent liver injury. The product label for tivozanib does not recommend routine monitoring of liver tests. But if found, serum aminotransferase elevations above 5 times ULN should lead to dose reduction or temporary cessation until the elevations are shown to have another cause or decrease into the normal or near normal range. ALT or AST elevations above 20 times ULN or any elevations accompanied by jaundice or symptoms should lead to discontinuation. There does not appear to be cross reactivity in risk for hepatic injury among the various kinase inhibitors but few instances have been studied.

Drug Class: Antineoplastic Agents, Protein Kinase Inhibitors

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Tivozanib – Fotivda®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?label=all&query=Tivozanib)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Tivozanib | 475108-18-0 | C22-H19-Cl-N4-O5

## ANNOTATED BIBLIOGRAPHY

References updated: 26 December 2023

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999 before the availability of tyrosine kinase inhibitors such as tivozanib).
DeLeve LD. Erlotinib. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 556. (Review of hepatotoxicity of cancer chemotherapeutic agents discusses several tyrosine kinase inhibitors including imatinib, gefitinib, erlotinib and crizotinib, but not tivozanib).
Wellstein A, Giaccone G, Atkins MB, Sausville EA. Pathway-targeted therapies: monoclonal antibodies, protein kinase inhibitors, and various small molecules. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1203-36. (Textbook of pharmacology and therapeutics).
FDA. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2021/212904Orig1s000MultidisciplineR.pdf (Integrated FDA review of the data on safety and efficacy of tivozanib that formed the basis of its approval, mentions that ALT elevations arose in 30% of patients and were above 5 times ULN in 3.6%, but these rates were similar to those in sorafenib-treated controls [29% and 2.4%], and while there were 4 serious “hepatobiliary” events [2.3%], none were attributed to tivozanib, most being due to hepatic metastases).
Nosov DA, Esteves B, Lipatov ON, Lyulko AA, Anischenko AA, Chacko RT, Doval DC, et al. Antitumor activity and safety of tivozanib (AV-951) in a phase II randomized discontinuation trial in patients with renal cell carcinoma. J Clin Oncol. 2012;30:1678–1685. (Among 172 patients with advanced or metastatic renal cell cancer treated with tivozanib or placebo for 12 weeks, progression free survival was increased by tivozanib [10.3 vs 3.3 months], while adverse events included ALT elevations in 29% of patients that were above 5 times ULN in only 1% ). 22493422
Motzer RJ, Nosov D, Eisen T, Bondarenko I, Lesovoy V, Lipatov O, Tomczak P, et al. Tivozanib versus sorafenib as initial targeted therapy for patients with metastatic renal cell carcinoma: results from a phase III trial. J Clin Oncol. 2013;31:3791–3799. (Among 517 patients with metastatic renal cell carcinoma treated with tivozanib or sorafenib, progression free survival was slightly longer with tivozanib [11.9 vs 9.1 months], while adverse events were common in both groups [94% vs 97%] and ALT elevations arose in 28% vs 34% and were above 5 times ULN in 2% vs 4%, and there were no liver related deaths with tivozanib but one with sorafenib). 24019545
Rini BI, Pal SK, Escudier BJ, Atkins MB, Hutson TE, Porta C, Verzoni E, et al. Tivozanib versus sorafenib in patients with advanced renal cell carcinoma (TIVO-3): a phase 3, multicentre, randomised, controlled, open-label study. Lancet Oncol. 2020;21:95–104. (Among 350 patients with refractory, metastatic renal cell cancer treated with tivozanib or sorafenib, progression free survival was longer with tivozanib [5.9 vs 3.9 months], while adverse event rates were 84% vs 94%, serious adverse event rates 11% vs 10%; no mention of ALT elevations but there were no treatment related deaths). 31810797
Albiges L, Barthélémy P, Gross-Goupil M, Negrier S, Needle MN, Escudier B. TiNivo: safety and efficacy of tivozanib-nivolumab combination therapy in patients with metastatic renal cell carcinoma. Ann Oncol. 2021;32:97–102. (Among 25 patients with metastatic renal cell carcinoma treated with tivozanib and nivolumab, the objective response rate was 55% and adverse event rate 80%, most frequently hypertension, fatigue and diarrhea, and ALT elevations in 16% which were above 5 times ULN in 1 patient [4%]). 33010459
Basso U, Procopio G, Fornarini G, Massari F, Bearz A, Fratino L, Milella M, et al. Safety and efficacy of tivozanib in first-line mRCC: a multicenter compassionate-use study (Meet-Uro 16). Oncology. 2021;99:747–755. (Among 64 patients with metastatic renal cell carcinoma treated with tivozanib in a compassionate use protocol, the objective response rate was 34% while the adverse event rate was 92%, the most common side effects being fatigue, hypothyroidism and hypertension, liver toxicity occurring in 4.7%, but no details provided). 34583356
Chang E, Weinstock C, Zhang L, Fiero MH, Zhao M, Zahalka E, Ricks TK, et al. FDA approval summary: tivozanib for relapsed or refractory renal cell carcinoma. Clin Cancer Res. 2022;28:441–445. (Summary of data on efficacy and safety of tivozanib that led to its FDA approval as therapy of patients with relapsed or refractory advanced renal cell carcinoma after two previous therapies; safety analyses were based upon 6 trials with 1008 treated patients; no mention of hepatotoxicity or ALT elevations). 34417198
Heseltine J, Allison J, Wong S, Prasad K, Oong ZC, Wong H, Law A, et al. Clinical outcomes of tivozanib monotherapy as first-line treatment for metastatic renal cell carcinoma: a multicentric UK real-world analysis. Target Oncol. 2023;18:593–599. (Among 113 patients with metastatic renal cell carcinoma treated in four cancer centers with tivozanib as a first line therapy, progression free survival was 8.8 months, and the adverse event rate 75% with “deranged liver function tests” in 4%, which were above 5 times ULN in 3%; no details given). 37285073

## OTHER REFERENCE LINKS

Recent References on Tivozanib: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Tivozanib+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

Trials on Tivozanib: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Tivozanib)